# Cariprazine

## OVERVIEW

### Introduction

Cariprazine is an atypical antipsychotic used in the treatment of schizophrenia and manic or mixed episodes of bipolar disorder. Cariprazine has been associated with a low rate of serum aminotransferase elevations during therapy, but it has not been linked to instances of clinically apparent acute liver injury.

### Background

Cariprazine (kar ip' ra zeen) is an atypical antipsychotic which appears to act as a partial agonist of dopamine type 2 (D2) and 3 (D3) receptors. The D2 and D3 receptors have been identified as targets for therapy of schizophrenia where they appear to be overstimulated. Cariprazine also may have some degree of activity against selected serotonin receptors (5-HT1A). In short term clinical trials, cariprazine was shown to improve symptoms in patients with schizophrenia and manic or mixed episodes of bipolar I disorder. Cariprazine was approved for these indications in the United States in 2015, and indications were expanded subsequently to include depressive episodes associated with bipolar disorder and as adjunctive therapy to antidepressants for adults with major depressive disorder. Cariprazine is available in capsules of 1.5, 3, 4.5 and 6 mg under the brand name Vraylar. The recommended initial dose is 1.5 mg once daily, with subsequent dose increases based upon efficacy and tolerance to 3 to 6 mg daily. Lower doses are recommended for bipolar depression and when cariprazine is used as adjunctive therapy. Common side effects include dizziness, sedation, somnolence, nausea, weight gain, restlessness, tremor, akathisia and extrapyramidal symptoms. More serious adverse events can include cerebrovascular events such as transient ischemic attacks, particularly in the elderly with dementia, neurologic malignant syndrome, tardive dyskinesia, seizures, marked weight gain, dyslipidemia, diabetes, and orthostatic hypotension. Like many antipsychotic medications, cariprazine has a boxed warning for excessive mortality in elderly patients with dementia-related psychosis and, like many antidepressants, it also has a boxed warning for increased risk of suicidal thoughts and behaviors.

### Hepatotoxicity

Serum aminotransferase elevations above 3 times the upper limit of normal occurred in 2% to 4% of patients treated with cariprazine in preregistration studies compared with 0.7% to 2% of placebo recipients. Elevations above 5 times ULN were rare <1% and no patient developed clinically apparent liver injury with jaundice or symptoms. Nevertheless, an occasional patient was withdrawn from therapy because of serum aminotransferase elevations usually arising within the first month of treatment and resolving rapidly with drug discontinuation. Since its approval and more widescale use, there have been no published cases of clinically apparent liver injury although the product label lists hepatitis as a possible adverse side effect.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which cariprazine causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate by its metabolism. Cariprazine is extensively metabolized by the liver via CYP 3A4 and is susceptible to drug-drug interactions with inhibitors or inducers of CYP 3A. Some instances of mild serum aminotransferase elevations occurring on cariprazine therapy may be due to nonalcoholic fatty liver disease caused by weight gain that generally occurs during the first 1 to 2 years of therapy.

### Outcome and Management

The serum aminotransferase elevations that occur on cariprazine therapy are usually self-limited and usually do not require dose modification or discontinuation of therapy. Elevations of serum ALT or AST above 5 times the upper limit of normal or any elevations accompanied by jaundice or symptoms should prompt temporary discontinuation until the clinical course of the injury and role of the drug are better defined. Cariprazine has not been implicated in cases of acute liver failure, chronic liver injury or vanishing bile duct syndrome. There is no evidence to suggest cross sensitivity to liver injury between cariprazine and other atypical antipsychotic agents.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cariprazine – Vraylar®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cariprazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cariprazine | 839712-12-8 | C21-H32-Cl2-N4-O

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
FDA: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2015/204370Orig1Orig2s000MedR.pdf (FDA website with product labels and initial medical review of data presented in support of its approval as therapy of schizophrenia; mentions that ALT or AST elevations arose in 1.7-3.1% of patients treated with cariprazine vs 0.7-2.1% of placebo recipients, but elevations were transient and not accompanied by symptoms or jaundice and one patient with preexisting ALT elevations was withdrawn from therapy when ALT arose to above 10 times ULN, but bilirubin and alkaline phosphatase remained normal and ALT levels returned to baseline after stopping).
Durgam S, Starace A, Li D, Migliore R, Ruth A, Németh G, Laszlovszky I. (2014). An evaluation of the safety and efficacy of cariprazine in patients with acute exacerbation of schizophrenia: a phase II, randomized clinical trial. Schizophr Res. (Among 732 adults with an acute exacerbation of schizophrenia treated with cariprazine [1.5, 3.0 and 4.5 mg] or risperidone [4 mg] or placebo daily for 6 weeks, improvement in symptom scores occurred in all treatment groups, and side effects that were more frequent with cariprazine than placebo were insomnia, extrapyramidal symptoms, akathisia, sedation, nausea, dizziness and constipation, while mean levels of ALT increased slightly [0.8 to 3.2 U/L] in a dose dependent manner with cariprazine, however there were no cases of clinically apparent liver injury).
Durgam S, Cutler AJ, Lu K, Migliore R, Ruth A, Laszlovszky I, Németh G, et al. (2015). Cariprazine in acute exacerbation of schizophrenia: a fixed-dose, phase 3, randomized, double-blind, placebo- and active-controlled trial. J Clin Psychiatry. (Among 617 patients with schizophrenia treated with cariprazine [3 or 6 mg], aripiprazole [10 mg] or placebo daily for 6 weeks, symptoms improved with cariprazine and aripiprazole compared to placebo, and side effects included insomnia, akathisia and headache).
Calabrese JR, Keck PE, Starace A, Lu K, Ruth A, Laszlovszky I, Németh G, et al. (2015). Efficacy and safety of low- and high-dose cariprazine in acute and mixed mania associated with bipolar I disorder: a double-blind, placebo-controlled study. J Clin Psychiatry. (Among 497 patients with acute and mixed mania due to bipolar I disorder treated with cariprazine or placebo for 3 weeks, mean serum ALT levels rose slightly [4-5 U/L vs 1 U/L with placebo], but mean AST, alkaline phosphatase or bilirubin values did not).
Kane JM, Zukin S, Wang Y, Lu K, Ruth A, Nagy K, Laszlovszky I, et al. (2015). Efficacy and safety of cariprazine in acute exacerbation of schizophrenia: results from an international, phase III clinical trial. J Clin Psychopharmacol. (Among 446 patients with an acute exacerbation of schizophrenia treated with cariprazine [3-9 mg] or placebo daily for 6 weeks, symptoms improved with cariprazine therapy and adverse events included akathisia, extrapyramidal symptoms and tremor, while ALT elevations above 3 times ULN occurred in 1% of all 3 groups, but led to discontinuation in 1 cariprazine treated subject).
Sachs GS, Greenberg WM, Starace A, Lu K, Ruth A, Laszlovszky I, Németh G, et al. (2015). Cariprazine in the treatment of acute mania in bipolar I disorder: a double-blind, placebo-controlled, phase III trial. J Affect Disord. (Among 312 patients with acute manic or mixed episodes due to bipolar I disorder treated with cariprazine [3-12 mg daily] or placebo for 3 weeks, symptom scores improved more with cariprazine while side effects included extrapyramidal symptoms, akathisia, tremor, dyspepsia and vomiting and mean changes in ALT levels were 13 vs 7 U/L; no mention of hepatotoxicity or liver related reason for discontinuation or dose modification).
McCormack PL. (2015). Cariprazine: First global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of cariprazine as therapy for schizophrenia and manic or mixed episodes of bipolar I disorder; mentions that cariprazine has been associated with a higher rate of liver enzyme elevations compared to placebo, but that no clinically apparent liver injury with jaundice occurred).
Durgam S, Earley W, Lipschitz A, Guo H, Laszlovszky I, Németh G, Vieta E, et al. (2016). An 8-week randomized, double-blind, placebo-controlled evaluation of the safety and efficacy of cariprazine in patients with bipolar I depression. Am J Psychiatry. (Among 571 patients with acute manic or mixed episodes due to bipolar I disorder treated with cariprazine [0.75, 1.5 and 3 mg daily] or placebo for 6 weeks, symptom scores improved more with cariprazine and side effects included akathisia, insomnia and weight gain; there were minimal changes in serum ALT and AST values and no instance of clinically apparent liver injury with jaundice).
Durgam S, Earley W, Li R, Li D, Lu K, Laszlovszky I, Fleischhacker WW, et al. (2016). Long-term cariprazine treatment for the prevention of relapse in patients with schizophrenia: A randomized, double-blind, placebo-controlled trial. Schizophr Res. (Among 200 patients with schizophrenia enrolled in an open label treatment study who were continued on cariprazine or placebo for up to 97 weeks, relapses occurred in 25% of cariprazine vs 48% of placebo recipients and there were slight increases in mean ALT levels, one patient developing ALT elevations and jaundice during cariprazine therapy).
(2016). Cariprazine (Vraylar) for schizophrenia and bipolar I disorder. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of cariprazine shortly after its approval for use in the US; mentions side effects of extrapyramidal symptoms, akathisia, dyspepsia, vomiting, somnolence, restlessness and weight gain, but not ALT elevations or hepatotoxicity).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Németh G, Laszlovszky I, Czobor P, Szalai E, Szatmári B, Harsányi J, Barabássy Á, et al. (2017). Cariprazine versus risperidone monotherapy for treatment of predominant negative symptoms in patients with schizophrenia: a randomised, double-blind, controlled trial. Lancet. (Among 461 adults with stable schizophrenia treated with cariprazine [3-6 mg] or risperidone [3-6 mg] daily for 26 weeks, symptom scores improved more with cariprazine and rates of adverse events were similar, mean ALT and AST levels changing minimally in both groups).
Earley W, Durgam S, Lu K, Debelle M, Laszlovszky I, Vieta E, Yatham LN. (2017). Tolerability of cariprazine in the treatment of acute bipolar I mania: A pooled post hoc analysis of 3 phase II/III studies. J Affect Disord. (Among 1065 patients with acute mania or mixed episode of bipolar I disorder treated with cariprazine or placebo for 3 weeks, adverse events more frequent with active treatment included akathisia, extrapyramidal symptoms, restlessness and vomiting; and while mean changes in ALT and AST were slightly higher with higher doses of cariprazine, there were no instances of clinically apparent liver injury with jaundice).
Durgam S, Greenberg WM, Li D, Lu K, Laszlovszky I, Nemeth G, Migliore R, et al. (2017). Safety and tolerability of cariprazine in the long-term treatment of schizophrenia: results from a 48-week, single-arm, open-label extension study. Psychopharmacology (Berl). (Among 93 patients who had a response during a 6 week controlled trial and were continued on cariprazine [1.5 to 4.5 mg/day] for another 48 weeks, side effects included akathisia, insomnia and weight gain and 13% of patients had a serious adverse event, but there were no “clinically meaningful changes from baseline” in liver tests and no discontinuation was attributed to liver injury).
Fava M, Durgam S, Earley W, Lu K, Hayes R, Laszlovszky I, Németh G. (2018). Efficacy of adjunctive low-dose cariprazine in major depressive disorder: a randomized, double-blind, placebo-controlled trial. Int Clin Psychopharmacol. (Among 231 patients with major depressive disorder with an inadequate response to antidepressant who were treated with addition of low or high dose cariprazine or placebo, there were numerically greater mean decreases in depression rating scores with the higher dose of cariprazine, and while adverse events were more frequent with cariprazine, mean changes in laboratory test results were “generally comparable across treatment groups” and there were no hepatic serious adverse events).
Earley W, Burgess MV, Rekeda L, Dickinson R, Szatmári B, Németh G, McIntyre RS, et al. (2019). Cariprazine treatment of bipolar depression: a randomized double-blind placebo-controlled phase 3 study. Am J Psychiatry. (Among 480 adults with bipolar depression treated with cariprazine [1.5 or 3.0 mg] or placebo once daily for 6 weeks, clinical depression scales improved more with cariprazine [-15.1 and -15.6 vs -12.6], while side effects that were more frequent with therapy included nausea, akathisia, dizziness, sedation, and weight gain, but changes in laboratory tests were “generally comparable among treatment groups”).
Earley WR, Burgess MV, Khan B, Rekeda L, Suppes T, Tohen M, Calabrese JR. (2020). Efficacy and safety of cariprazine in bipolar I depression: A double-blind, placebo-controlled phase 3 study. Bipolar Disord. (Among 493 adults with bipolar depression treated with cariprazine [1.5 or 3.0 mg daily] or placebo for 6 weeks, clinical depression scores improved more with cariprazine [-14.8 and -14.1 vs -12.4] but was significant only for the lower dose, while adverse events included nausea, fatigue, akathisia, and restlessness, but changes in laboratory values were comparable across treatment groups and there were no cases of clinically apparent liver injury or hepatic serious adverse events).
Yatham LN, Vieta E, Earley W. (2020). Evaluation of cariprazine in the treatment of bipolar I and II depression: a randomized, double-blind, placebo-controlled, phase 2 trial. Int Clin Psychopharmacol. (Among 233 patients with bipolar depression treated with low or high doses of cariprazine or placebo for 6 weeks, there were no differences in improvements in depression scores in the 3 groups, but adverse events were more frequent with cariprazine including akathisia, nausea, somnolence, and weight gain, while changes in laboratory values including serum ALT and AST were similar among the 3 groups).
Earley WR, Burgess M, Rekeda L, Hankinson A, McIntyre RS, Suppes T, Calabrese JR, et al. (2020). A pooled post hoc analysis evaluating the safety and tolerability of cariprazine in bipolar depression. J Affect Disord. (Among 2745 patients with bipolar depression enrolled in 6 clinical trials of cariprazine, adverse events were slightly more frequent with cariprazine than placebo [60% vs 55%], but there were few and only slight changes in laboratory values and no episodes of clinically apparent liver injury with jaundice).
Heck J, Seifert J, Stichtenoth DO, Schroeder C, Groh A, Szycik GR, Degner D, et al. (2021). A case series of serious and unexpected adverse drug reactions under treatment with cariprazine. Clin Case Rep. (Four case reports of severe, unexpected adverse reactions to cariprazine therapy including severe akathisia, parkinsonism and hypokinesia, acute psychosis, and hyperprolactinemia; no mention of ALT elevations or hepatotoxicity).
Barabássy Á, Sebe B, Acsai K, Laszlovszky I, Szatmári B, Earley WR, Németh G. (2021). Safety and tolerability of cariprazine in patients with schizophrenia: a pooled analysis of eight phase II/III studies. Neuropsychiatr Dis Treat. (In a pooled analysis based upon 2048 patients enrolled in 8 clinical trials of cariprazine for schizophrenia, the most frequent adverse events were akathisia [15%], insomnia [14%], headache [12%], and weight gain [5%] and there was a “small increase” in ALT and AST levels relative to placebo [~4 U/L]; no mention of episodes of marked ALT elevations or hepatotoxicity).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
(2023). Cariprazine (Vraylar) for adjunctive treatment of depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of cariprazine as an adjunctive therapy for major depression resistant to conventional antidepressants; no mention of ALT elevations or hepatotoxicity).
Sachs GS, Yeung PP, Rekeda L, Khan A, Adams JL, Fava M. (2023). Adjunctive cariprazine for the treatment of patients with major depressive disorder: a randomized, double-blind, placebo-controlled phase 3 study. Am J Psychiatry. (Among 751 patients with refractory major depressive disorder treated with cariprazine [1.5 or 3.0 mg] or placebo once daily for 6 weeks, depression rating scores improved more with cariprazine [-14.1 and -13.0 vs -11.5], while remission rates were similar and adverse events included akathisia, nausea, insomnia, somnolence and weight gain, but laboratory values were “generally comparable” among groups; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Cariprazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cariprazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cariprazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cariprazine)